# Isatuximab

Short Chapter

[Preliminary review chapter based on the FDA Product Labeling and Integrated Review only.]

## OVERVIEW

### Introduction

Isatuximab is a cytolytic monoclonal antibody to CD38 used in the therapy of multiple myeloma in combination with pomalidomide and dexamethasone. The addition of isatuximab to pomalidomide and dexamethasone increases the rate of severe infections and serious adverse events associated with pomalidomide and dexamethasone alone, but does not increase the rate of serum ALT, AST or bilirubin elevations. Since its more widespread clinical use, isatuximab has not been implicated in cases clinically apparent liver injury.

### Background

Isatuximab (eye” sa tux’ i mab) is a cytolytic, chimeric monoclonal antibody to CD38, a cell surface antigen expressed on hematopoietic and tumor cells including multiple myeloma cells. Studies in cell culture and animal models demonstrated that isatuximab was cytotoxic to malignant multiple myeloma cells. In clinical trials in patients with advance multiple myeloma refractory to standard therapies, the addition of isatuximab to pomalidomide and dexamethasone increased progression-free survival (11.5 vs 6.5 months). Isatuximab was approved in the United States in 2020 as therapy for adults with progressive multiple myeloma after having received two prior therapies including lenalidomide and a proteasome inhibitor. Subsequently, the indications were expanded to include isatuximab in combination with carfilzomib (a proteasome inhibitor) and dexamethasone in patients with refractory or relapsed multiple myeloma after 3 prior therapies. Isatuximab is available in single dose vials of 100 mg in 5 mL and 500 mg in 25 mL (both 20 mg/mL) for intravenous infusion. The recommended dose is 10 mg per kg body weight once weekly for 4 weeks followed by every 2 weeks in combination with the other antineoplastic agents until disease progression or unacceptable toxicity. Combination isatuximab therapy of multiple myeloma has many adverse events and the serious adverse event rates are higher with the addition of isatuximab to pomalidomide and dexamethasone (85% vs 54%), and are mostly severe infusion reactions or myelosuppression, including neutropenia, anemia, lymphopenia, and thrombocytopenia. Rare but potentially severe adverse events include secondary malignancies, and embryo-fetal toxicity.

### Hepatotoxicity

Serum ALT elevations developed in 36% of patients receiving isatuximab based chemotherapy vs 31% with pomalidomide and dexamethasone alone and were above 5 times the upper limit of normal in 4% vs 3%. Bilirubin elevations were also frequent with both arms, 16% vs 12%. But no patient developed what was considered drug induced liver injury, the liver test abnormalities being attributed to comorbidities and the advanced stage of multiple myeloma. Since its approval and more widescale use, there have been no published cases of clinically apparent liver injury attributed to isatuximab therapy, although its total clinical experience with its use has been limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury although a potential cause of reactivation of hepatitis B).

### Mechanism of Injury

Isatuximab is a monoclonal antibody and is metabolized intracellularly by proteases to short polypeptides and amino acids, which are unlikely to have intrinsic toxicity or to induce immunologically mediated injury. Because it causes some degree of immune suppression, isatuximab may be capable of causing reactivation of hepatitis B virus. Cases of reactivation of varicella virus infection have been reported.

### Outcome and Management

The product label for isatuximab does not recommend monitoring of routine liver tests during therapy, but testing patients before starting therapy is appropriate because of the frequency of comorbidities including liver disease in patients with advanced multiple myeloma. Testing for HBsAg and anti-HBc might also be recommended because of the risk of reactivation. Rise in serum aminotransferase levels during therapy should trigger evaluation for other possible causes. Persistence of unexplained ALT levels above 5 times the ULN or appearance of symptoms of liver injury or jaundice should lead to at least temporary discontinuation and more careful monitoring. Pomalidomide is known to be a rare cause of liver injury, and it might be suspected as the culprit in patients receiving it in combination with isatuximab.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Isatuximab – Sarclisa®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Isatuximab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
isatuximab | 1461640-62-9 (https://pubchem.ncbi.nlm.nih.gov/substance/381127523) | Monoclonal Antibody | Not Available

## BIBLIOGRAPHY

References updated: 14 May 2024

Abbreviations: ULN, upper limit of normal range.

[Short Chapter information is based largely on FDA Product Labeling and the FDA Integrated Review accessible from the FDA website https://www.accessdata.fda.gov/scripts/cder/daf/index.cfm. All other references have not been fully reviewed and annotated.]

FDA. Integrated Review. 2020.
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/761113Orig1s000MultidisciplineR.pdf (FDA Integrated review of the data on isatuximab safety and efficacy submitted in support of the application for approval as therapy of multiple myeloma mentions that ALT elevations arose in 36% [4% above 5 times ULN] of patients receiving isatuximab vs 31% [3% above 5 times ULN] with pomalidomide and dexamethasone alone, and there were no serious or fatal liver related adverse events attributable to therapy with isatuximab).
Attal M, Richardson PG, Rajkumar SV, San-Miguel J, Beksac M, Spicka I, Leleu X, et al.; ICARIA-MM study group. Isatuximab plus pomalidomide and low-dose dexamethasone versus pomalidomide and low-dose dexamethasone in patients with relapsed and refractory multiple myeloma (ICARIA-MM): a randomised, multicentre, open-label, phase 3 study. Lancet. 2019;394:2096-2107.31735560
Delgado J, Zienowicz M, van Hennik PB, Moreau A, Gisselbrecht C, Enzmann H, Pignatti F. EMA review of isatuximab in combination with pomalidomide and dexamethasone for the treatment of adult patients with relapsed and refractory multiple myeloma. Oncologist. 2021;26:983-987.34213061
Boissel N, Chevallier P, Doronin V, Griskevicius L, Maschan A, McCloskey J, Rambaldi A, et al. Isatuximab monotherapy in patients with refractory T-acute lymphoblastic leukemia or T-lymphoblastic lymphoma: Phase 2 study. Cancer Med. 2022;11:1292-1298.35106962
Goldschmidt H, Mai EK, Bertsch U, Fenk R, Nievergall E, Tichy D, Besemer B, et al.; German-Speaking Myeloma Multicenter Group (GMMG) HD7 investigators. Addition of isatuximab to lenalidomide, bortezomib, and dexamethasone as induction therapy for newly diagnosed, transplantation-eligible patients with multiple myeloma (GMMG-HD7): part 1 of an open-label, multicentre, randomised, active-controlled, phase 3 trial. Lancet Haematol. 2022;9(11):e810-e821.36328040
Nadeau Nguyen M, Dores GM, Nayernama A, Jones SC. Varicella zoster virus reactivation reported with isatuximab use. J Chemother. 2024;36:198-201.37800850

## OTHER REFERENCE LINKS

1. Recent References on Isatuximab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Isatuximab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Isatuximab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Isatuximab)